# Flecainide

## OVERVIEW

### Introduction

Flecainide is an oral antiarrhythmic agent that has been in use for several decades. Long term flecainide therapy is associated with a low rate of serum enzyme elevations and is a very rare cause of clinically apparent acute liver injury.

### Background

Flecainide (fle kay' nide) is a benzamide derivative analogue of the local anesthetic procaine and has electrophysiological effects that resemble quinidine (antiarrhythmic Class IC). Flecainide appears to act by blocking open sodium channels and outward potassium channels. As a consequence, it decreases cardiac automaticity, increases refractory periods and slows conduction. Flecainide was approved for use in the United States in 1985. Its current indications include prevention and suppression of life threatening ventricular arrhythmias and conversion of supraventricular tachyarrhythmias and subsequent maintenance of normal sinus rhythm in patients without structural heart disease, in whom other agents were unsuccessful. Flecainide is available in tablets of 50, 100 and 150 mg generically and under the brand name Tambocor. The usual maintenance dose in adults is 50 to 200 mg twice daily. The most common side effects include dizziness, visual blurring, headache, fatigue, anxiety, gastrointestinal upset and nausea.

### Hepatotoxicity

In clinical trials, flecainide was associated with a low rate of serum aminotransferase and alkaline phosphatase elevations. Despite wide scale use, flecainide has only rarely been linked to cases of clinically apparent liver injury. The typical presentation is with a cholestatic hepatitis arising within 1 to 6 weeks of starting flecainide. In addition, instances of acute hepatic injury arising within 1 to 3 days of starting flecainide with marked, but short lived elevations in serum aminotransferase levels and minimal increases in alkaline phosphatase have been published, but may actually represent acute worsening of congestive heart failure and ischemic hepatitis due to the proarrhythmic effects of flecainide. In all instances, the liver injury was self limited. Immunoallergic and autoimmune features were not present.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which flecainide might cause liver injury is unknown. Flecainide is metabolized in the liver predominantly by CYP 2D6. In some instances, symptoms and liver test abnormalities may be due to worsening of congestive heart failure and hepatic congestion.

### Outcome and Management

Liver injury due to flecainide is rare and usually mild. Cases of prolonged jaundice, but no reports of acute liver failure, chronic hepatitis or vanishing bile duct syndrome attributed to flecainide, have been published. There is little information about cross sensitivity to liver injury between flecainide and other oral antiarrhythmics, but such shared sensitivity is unlikely.

Drug Class: Antiarrhythmic Agents

## CASE REPORT

### Case 1. Cholestatic hepatitis due to flecainide.

[Modified from: Mikloweit P, Bienmüller H. [Drug-induced intrahepatic cholestasis caused by flecainide acetate and enalapril]. Internist (Berl) 1987; 28: 193-5. German. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/3034817)]

A 64 year old man developed abnormal liver tests five weeks after starting flecainide for cardiac tachyarrhythmias. He had a history of coronary artery disease and had been hospitalized for acute myocardial infarction, during which he had several episodes of ventricular tachycardia treated with lidocaine and then with oral flecainide (200 mg daily). His other medications included furosemide, spironolactone, metoprolol, glibecamide, and coumadin. Five weeks after starting flecainide therapy, laboratory testing demonstrated a total serum bilirubin of 3.0 mg/dL and alkaline phosphatase 310 U/L (Table). Flecainide was stopped the following day, but serum alkaline phosphatase levels continued to rise. He was started on propafenone. Tests for hepatitis B were negative and ultrasonography showed no evidence of biliary obstruction. A liver biopsy showed a cholestatic hepatitis with portal inflammation. Thereafter, serum bilirubin levels and alkaline phosphatase levels began to improve. Limited follow up was provided. [A second case of cholestatic hepatitis in this publication was attributed to enalapril]

#### Key Points

Medication: | Flecainide (200 mg daily)
Pattern: | Cholestatic (R=0.7)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 5 weeks
Recovery: | Unclear
Other medications: | Glyburide, metoprolol, furosemide, spironolactone, warfarin, and lidocaine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 15 | 145 | 0.9 | Hospital admission
2 weeks | | 25 | 115 | 0.8
5 weeks | 0 | 45 | 310 | 3.0 | Jaundice
| 2 days | 50 | 420 | 7.6
6 weeks | 8 days | 40 | 479 | 4.2 | Liver biopsy
7 weeks | 12 days | 40 | 340 | 2.5
Normal Values | | <31 | <130 | <1.2

#### Comment

This patient developed cholestatic hepatitis 5 weeks after starting flecainide with improvements starting within a few days of stopping therapy. The cholestatic picture, timing of onset and lack of other known hepatotoxic exposures make flecainide a likely cause.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Flecainide – Generic, Tambocor®

DRUG CLASS

Antiarrhythmic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Flecainide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Flecainide | 54143-56-5 | C17-H20-F6-N2-O3.C2-H4-O2 | Chemical Structure for Flecainide

## ANNOTATED BIBLIOGRAPHY

References updated: 24 Janurary 2018

Zimmerman HJ. Antiarrhythmics. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 642-4. (Expert review of hepatotoxicity of antiarrhythmics and procainamide published in 1999; mentions that flecainide has been linked to rare cases of cholestatic jaundice).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of cardiovascular agents, mentions that flecainide has been linked to rare cases of hepatocellular injury that is rapidly reversible).
Sampson KJ, Kass RS. Antiarrhythmic drugs. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 815-48. (Textbook of pharmacology and therapeutics).
Hopmann G, Surmann T. [Cholestatic jaundice during flecainide therapy]. Dtsch Med Wochenschr 1984; 109: 1863. German. (61 year old man developed nausea followed by jaundice 30 days after starting flecainide for ventricular arrhythmias [peak bilirubin 15.8 mg/dL, ALT 71 U/L, Alk P 585 U/L] with slow recovery, symptoms resolving after 2, jaundice 3.5 and liver enzymes 5 months after stopping). 6499688
Mikloweit P, Bienmüller H. [Drug-induced intrahepatic cholestasis caused by flecainide acetate and enalapril]. Internist (Berl) 1987; 28: 193-5. German. (64 year old man developed jaundice 5 weeks after starting flecainide [peak bilirubin 7.6 mg/dL, ALT 152 U/L, Alk P 479 U/L, eosinophils 6%], resolving upon switching to propafenone: Case 1). 3034817
Kühlkamp V, Haasis R, Seipel L. [Flecainide-induced hepatitis]. Z Kardiol 1988; 77: 678-80. German. (51 year old man developed nausea and abdominal pain 2 days after starting flecainide [ALT 993 U/L, bilirubin 3.0 mg/dL, Alk P normal], resolving within 2 weeks of stopping). 3149084
Flecainide for supraventricular tachyarrhythmias. Med Lett Drugs Ther 1992; 34: 71-2. (Short summary of efficacy and safety of flecainide published soon after its approval in the US; adverse effects include dizziness and blurred vision, but recommended restricted use because of its proarrhythmic effects). 1630411
Echt DS, Liebson PR, Mitchell LB, Peters RW, Obias-Manno D, Barker AH, Arensberg D, et al. Mortality and morbidity in patients receiving encainide, flecainide, or placebo. The Cardiac Arrhythmia Suppression Trial. N Engl J Med 1991; 324: 781-8. (Among 1498 patients with myocardial infarction and ventricular ectopy, 323 were treated with flecainide and 318 with placebo and followed for a mean of 10 months; there was an excess mortality from cardiac arrest in antiarrhythmic treated patients; no mention of hepatotoxicity or ALT elevations). 1900101
Roden DM. Antiarrhythmic drugs: from mechanisms to clinical practice. Heart 2000; 84: 339-46. (Overview of antiarrhythmic drugs which are separated into four classes based upon molecular target: I being sodium channel blockers; II beta blockers; III potassium channel blockers; and, IV calcium channel blockers; some agents having multiple targets). 10956304
McNamara RL, Tamariz LJ, Segal JB, Bass EB. Management of atrial fibrillation: review of the evidence for the role of pharmacologic therapy, electrical cardioversion, and echocardiography. Ann Intern Med 2003; 139: 1018-33. (Systematic review of literature on efficacy and safety of drugs for atrial fibrillation; flecainide has been shown to be effective in conversion of atrial fibrillation to normal sinus rhythm; hepatic side effects are not discussed). 14678922
Drugs for cardiac arrhythmias. Treat Guidel Med Lett 2007; 5: 51-8. (Concise review of drugs for arrhythmias; flecainide is effective in preventing supraventricular tachycardia and atrial fibrillation in “otherwise healthy hearts” and in suppressing ventricular arrhythmias, but has been associated with an increase in mortality after myocardial infarction; no mention of hepatotoxicity as an adverse event). 17505408
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34 (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to flecainide). 18955056
Tamargo J, Capucci A, Mabo P. Safety of flecainide. Drug Saf 2012; 35: 273-89. (Review of the use and safety of flecainide mentions rare reports of serum aminotransferase elevations and hepatic dysfunction, including cholestasis and hepatic failure: "However, no causal relationship has been established"). 22435343
Gao S, Dai W, Zhang L, Juhaeri J, Wang Y, Caubel P. Risk of Cardiovascular Events, Stroke, Congestive Heart Failure, Interstitial Lung Disease, and Acute Liver Injury: Dronedarone versus Amiodarone and Other Antiarrhythmics. J Atr Fibrillation 2013; 6: 890. (Analysis of health care database of 10,455 adults with atrial fibrillation or flutter seen between 2009 and 2010 treated with antiarrhythmics for serious outcomes found no difference in incidence [per 1000 person years] of acute liver injury for flecainide [5], dronedarone [7.6], propafenone [14] or even amiodarone [18.9]). 28496906
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/24552865) (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to flecainide).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/25754159) (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were due to flecainide).
Jenkins DJA, Freeman M, Mangat I, Srichaikul K, Jayalath VH, Faulkner D, Sievenpiper JL, et al. Flecainide and elevated liver enzymes in α1-antitrypsin deficiency. HeartRhythm Case Rep 2016; 2: 237-240. (72 year old man with atrial fibrillation developed abdominal discomfort and liver test abnormalities within days of starting metoprolol and flecainide [ALT ~200 U/L], which resolved within 10 days of stopping and recurred [ALT 60 U/L] with restarting flecainide). 28491677

## OTHER REFERENCE LINKS

1. Recent References on Flecainide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Flecainide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Flecainide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Flecainide)